# Gabapentin Enacarbil

## OVERVIEW

### Introduction

Gabapentin enacarbil is a long acting form of gabapentin that is used for restless leg syndrome and for painful postherpetic neuropathy. Gabapentin enacarbil and gabapentin are associated with a low rate of transient serum enzyme elevations during treatment and with rare instances of clinically apparent liver injury.

### Background

Gabapentin enacarbil (gab" a pen' tin) enacarbil (en" a kar' bil) is a prodrug of and long acting form of gabapentin. Gabapentin and its derivative gabapentin enacarbil do not appear to act upon gaba-ergic transmission, but appear to bind and perhaps inhibit presynaptic, voltage dependent calcium channels which play a role in normal and abnormal neurotransmission. In several prelicensure controlled trials, gabapentin enacarbil given in once daily doses was found to decrease symptoms of restless leg syndrome and postherpetic neuralgia. It has also been studied in other neuropathic pain syndromes, but with less obvious beneficial effects. Gabapentin enacarbil was approved for use in the United States in 2011 for the therapy of restless leg syndrome and postherpetic neuralgia. It is not approved as therapy for epilepsy, a major current indication for gabapentin itself. Gabapentin enacarbil is available in extended release tablets of 300 and 600 mg under the brand name Horizant. The typical dose is 600 to 1,200 mg once daily. Side effects may include somnolence, headache, dizziness, ataxia, blurred vision, nausea, fatigue and tremor.

### Hepatotoxicity

In prelicensure clinical trials, gabapentin enacarbil was not linked to an increased rate of serum enzyme elevations during treatment or to episodes of clinically apparent acute liver injury. Gabapentin has been implicated in isolated cases of acute liver injury, but in most instances the association was weakened by the coadministration with other potentially hepatotoxic agents. Too few cases have been reported in sufficient detail to characterize the clinical features of the associated injury. No published case has specifically implicated gabapentin enacarbil. Thus, gabapentin enacarbil may be associated with isolated instances of clinically apparent liver injury, but they must be rare, if they occur at all.

Likelihood score: E* (unproven but suspected cause of liver injury).

### Mechanism of Injury

Gabapentin enacarbil is hydrolyzed to gabapentin in the gastrointestinal tract. Gabapentin itself undergoes little subsequent metabolism and is excreted in the urine unchanged. Gabapentin and gabapentin enacarbil do not induce or inhibit the drug metabolizing, microsomal cytochrome P450 enzymes. The possible mechanism by which gabapentin might cause hepatic injury is not known, but may relate to a hypersensitivity reaction.

### Outcome and Management

Gabapentin enacarbil is metabolized to gabapentin and its side effect profile is similar, suggesting that it should not be used in patients with severe adverse reactions to gabapenin. There is no information on the possible cross sensitivity to hepatotoxicity between gabapentin enacarbil and other anticonvulsants, but its structure would suggest that there should not be shared sensitivity.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Gabapentin Enacarbil – Horizant®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Gabapentin&Enacarbil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Gabapentin Enacarbil | 478296-72-9 | C16-H27-N-O6 | Gabapentin Enacarbil chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 February 2018

Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013 does not discuss either gabapentin or gabapentin enacarbil).
Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999 before the availability of gabapentin enacarbil).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-42. (Review of anticonvulsant induced liver injury; gabapentin, but not its enacarbil is discussed).
McNamara JO. Pharmacotherapy of the epilepsies. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, p. 602. (Textbook of pharmacology and therapeutics).
Galindo PA, Borja J, Gómez E, Mur P, Gudín M, García R, Encinas C, et al. Anticonvulsant drug hypersensitivity. J Investig Allergol Clin Immunol 2002; 12: 299-304. (Among 15 patients with cutaneous hypersensitivity reactions to anticonvulsants [9 accompanied by liver test elevations] which were caused by carbamazepine [n=8], phenytoin [5], lamotrigine [4], phenobarbital [4], valproate [1] and felbamate [1], one of whom later tolerated gabapentin without recurrence). 12926190
Himmerich H, Nickel T, Dalal MA, Müller MB. [Gabapentin treatment in a female patient with panic disorder and adverse effects under carbamazepine during benzodiazepine withdrawal]. Psychiatr Prax 2007; 34: 93-4. German. (70 year old woman developed serum enzyme elevations on melperone and carbamazepine [ALT 103 U/L], but then tolerated gabapentin without recurrence). 17124639
Kummer O, Hammann F, Bodmer M, Novakova K, Krähenbühl S, Haschke M. [Drug-induced toxic hepatitis]. Praxis (Bern 1994) 2008; 97: 235-9; German. (55 year old man developed jaundice 12 days after starting a Chinese herbal medication called Hong Hua and while receiving gabapentin, resolving within 3 months of stopping all medications). 18548805
Björnsson E. Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scan 2008; 118: 281-90. (Review of all anticonvulsant induced liver injury; neither gabapentin nor pregabalin are discussed). 18341684
Bogan RK, Bornemann MA, Kushida CA, Trân PV, Barrett RW; XP060 Study Group. Long-term maintenance treatment of restless legs syndrome with gabapentin enacarbil: a randomized controlled study. Mayo Clin Proc 2010; 85: 512-21. (Among 194 patients treated with gabapentin enacarbil [1200 mg daily] or placebo for 12 weeks after receiving the active drug for at least 24 weeks, somnolence and dizziness were the most common adverse events and “there were no clinically relevant changes in laboratory values…for either phase or treatment group”). 20511481
Gabapentin encarbil (Horizant) for restless leg syndrome. Med Lett Drugs Ther 2011; 53 (1372): 70-1. (Concise review of the pharmacology, clinical efficacy, adverse events and costs of gabapentin encarbil, shortly after its approval for restless leg syndrome in the US, mentions its common side effects of somnolence, dizziness, ataxia, edema, weight gain, blurred vision, disorientation, lethargy and vertigo, but does not mention ALT elevations or hepatotoxicity). 21897349
Lee DO, Ziman RB, Perkins AT, Poceta JS, Walters AS, Barrett RW; XP053 Study Group. A randomized, double-blind, placebo-controlled study to assess the efficacy and tolerability of gabapentin enacarbil in subjects with restless legs syndrome. J Clin Sleep Med 2011; 7: 282-92. (Among 325 patients with restless leg syndrome treated with gabapentin enacarbil [600 or 1200 mg daily] or placebo for 12 weeks, common side effects included dizziness and somnolence and there were no serious hepatic adverse events; “no clinically relevant changes in…laboratory parameters were observed”). 21677899
Ellenbogen AL, Thein SG, Winslow DH, Becker PM, Tolson JM, Lassauzet ML, Chen D. A 52-week study of gabapentin enacarbil in restless legs syndrome. Clin Neuropharmacol 2011; 34: 8-16. Med (Among 573 patients with restless leg syndrome who participated in randomized controlled trials who were enrolled in a 52 week open label extension study of gabapentin enacarbil [600-1800 mg daily], 20 patients had a serious adverse reaction, but none were liver related and there were “no clinically relevant changes” in laboratory parameters, although five patients withdrew from therapy because of elevations in serum enzymes including ALT [peak values 75 to 154 U/L]). 21242741
Lal R, Ellenbogen A, Chen D, Zomorodi K, Atluri H, Luo W, Tovera J, et al. A randomized, double-blind, placebo-controlled, dose-response study to assess the pharmacokinetics, efficacy, and safety of gabapentin enacarbil in subjects with restless legs syndrome. Clin Neuropharmacol 2012; 35: 165-73. (Among 217 patients with restless leg syndrome treated with gabapentin enacarbil [600, 1200, 1800 or 2400 mg daily] or placebo for 12 weeks, drug levels and side effects were dose related, but there were no hepatic serious adverse events and “no clinically significant changes in…laboratory parameters were observed”). 22664749
Hayes WJ, Lemon MD, Farver DK. Gabapentin enacarbil for treatment of restless legs syndrome in adults. Ann Pharmacother 2012; 46: 229-39. (Systematic review of the literature on use of gabapentin enacarbil for restless leg syndrome, mentions neuropsychiatric adverse events, but not hepatotoxicity or ALT elevations). 22298601
Harden RN, Freeman R, Rainka M, Zhang L, Bell C, Berges A, Chen C, et al. A phase 2a, randomized, crossover trial of gabapentin enacarbil for the treatment of postherpetic neuralgia in gabapentin inadequate responders. Pain Med 2013; 14: 1918-32. (Among 94 patients with postherpetic neuralgia treated with 1200 or 3600 mg of gabapentin enacarbil daily, no patient had to stop therapy because of liver injury and there were no differences in laboratory tests between the two doses). 24102928
Zhang L, Rainka M, Freeman R, Harden RN, Bell CF, Chen C, Graff O, et al. A randomized, double-blind, placebo-controlled trial to assess the efficacy and safety of gabapentin enacarbil in subjects with neuropathic pain associated with postherpetic neuralgia (PXN110748). J Pain 2013; 14: 590-603. (Among 371 patients with postherpetic neuralgia treated with 1 of 3 doses of gabapentin enacarbil or placebo for 14 weeks, “there were no noticeable differences among groups” in laboratory test results). 23602345
Nagandla K, De S. Restless legs syndrome: pathophysiology and modern management. Postgrad Med J 2013; 89: 402-10. (Review of the clinical features, pathophysiology and treatment of restless leg syndrome; no discussion of side effects of most agents or mention of ALT elevations or hepatotoxicity). 23524988
Rauck R, Makumi CW, Schwartz S, Graff O, Meno-Tetang G, Bell CF, Kavanagh ST, McClung CL. A randomized, controlled trial of gabapentin enacarbil in subjects with neuropathic pain associated with diabetic peripheral neuropathy. Pain Pract 2013; 13: 485-96. (Among 421 adults with diabetic neuropathy treated with 1 of 3 doses of gabapentin enacarbil or pregabalin or placebo for 20 weeks, pain intensity scores did not change from baseline to a significant extent in any group, while side effects were greater with the drug treatments, although “there were no systematic changes noted in laboratory parameters”). 23186035
Silberstein S, Goode-Sellers S, Twomey C, Saiers J, Ascher J. Randomized, double-blind, placebo-controlled, phase II trial of gabapentin enacarbil for migraine prophylaxis. Cephalalgia 2013; 33: 101-11. (Among 523 patients with migraine treated with gabapentin enacarbil [1200-300 mg daily] or placebo for 20 weeks, there was no decrease in frequency of migraine headaches with treatment, no hepatic serious adverse events, and “no significant changes in laboratory values”). 23165696
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Concise review of indications and side effects of anticonvulsants; gabapentin is approved for use in partial seizures and neuropathic pain and its prodrug, gabapentin enacarbil, is approved for restless leg syndrome, but not for epilepsy). 23348233
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96, none were attributed to gabapentin enacarbil). 23419359
Fuzier R, Serres I, Guitton E, Lapeyre-Mestre M, Montastruc JL; French Network of Pharmacovigilance Centres. Adverse drug reactions to gabapentin and pregabalin: a review of the French pharmacovigilance database. Drug Saf 2013; 36: 55-62. (Among 725 spontaneous adverse event reports related to gabapentin made to the French Pharmacovigilance System between 1995 and 2009, liver ranked second to neuropsychiatric reactions in frequency [n=90, 12%], 37 of which were “hepatitis”, half of which were serious, 8 were “probable” or “likely” and one fatal, but no specific details given). 23315296
Gabapentin and pregabalin: hepatic and haematological toxicity. Prescrire Int 2014; 23 (154): 267. (Review of spontaneous reports of adverse events attributed to gabapentin from a French registry [Fuzier 2013] identified 90 cases of liver damage, gabapentin being the only suspect drug in 10 cases, one of which was fatal). 25954794
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were attributed to anticonvulsants, including 3 to gabapentin, but none specifically to gabapentin enacarbil). 25754159
Zaccara G, Giovannelli F, Giorgi FS, Franco V, Gasparini S, Benedetto U. Tolerability of new antiepileptic drugs: a network meta-analysis. Eur J Clin Pharmacol 2017; 73: 811-7. (Metanalysis of the comparative tolerability of 18 new anticonvulsant agents including gabapentin, found lowest rates of withdrawal for adverse events with levetiracetam, brivaracetam, and gabapentin with highest rates with eslicarbazepine, oxcarbazepine, lacosamide and topiramate). 28378057
Drugs for epilepsy. Med Lett Drugs Ther 2017; 59 (1526): 121-30. (Concise review of the drugs available for therapy of epilepsy lists gabapentin enacarbil as a form of gabapentin approved for use in restless leg syndrome and mentions common side effects of gabapentin being somnolence, dizziness, ataxia, fatigue, blurred vision and confusion; no mention of ALT elevations or hepatotoxicity). 28746301
Vidaurre J, Gedela S, Yarosz S. Antiepileptic Drugs and Liver Disease. Pediatr Neurol 2017; 77: 23-36. (Summary of the hepatotoxicity of major anticonvulsant medications including gabapentin which has no hepatic metabolism, so specific recommendation for dose modification because of liver disease, a minimal potential for drug-interations and low assocation with hepatotoxicity). 29097018

## OTHER REFERENCE LINKS

1. Recent References on Gabapentin Enacarbil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Gabapentin+Enacarbil+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Gabapentin Enacarbil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Gabapentin+Enacarbil)